# St. John's Wort

## OVERVIEW

### Introduction

St. John’s wort is a popular herbal medication and extract derived from the plant Hypericum perforatum which is purported to be beneficial in depression and anxiety. St. John’s wort has not been implicated convincingly in cases of clinically apparent, acute liver injury, although it may increase the hepatotoxicity of other agents by herb-drug interactions that alter drug metabolism.

### Background

St. John’s wort (saynt jonz wort) is an extract prepared from the flowers and leaves of a flowering plant native to Europe commonly known as St. John’s wort, Tipton’s weed or chase-devil (Hypericum perforatum). St. John’s wort is a yellow flowering perennial herb indigenous to Europe that has been introduced elsewhere. Its name refers to the Saint’s day on which it is typically harvested – June 24th. The genus name Hypericum means “above the picture” in reference to its use to ward off evil by hanging the plant over a religious picture or icon. St. John’s wort is an invasive weed in many countries where it has been introduced, where it can be toxic to livestock. St. John’s wort has been used widely as an herbal treatment for depression. It is available as an over-the-counter herbal in the United States, but in other countries is actively prescribed for mild-to-moderate depression. Extracts of St. John’s wort contain many polyphenols, including flavonoids (rutin, hyperoside, isoquercetin, quercitrin, quercetin and others), phenolic acids, naphthodianthrones (hypericin, pseudohypericin, protohypericin and others), and phloroglucinols (hyperforin, adhyperforin). The active principle responsible for the antidepressant effects of St. John’s wort is not known, the most likely candidates being hypericin, pseudohypericin and hyperforin. In controlled trials, St. John’s wort has shown evidence of an antidepressant effect in patients with mild to moderate depression. Side effects can occur with St. John’s wort including gastrointestinal upset, dizziness, confusion, fatigue, anxiety and photosensitivity. Importantly, St. John’s wort has effects on the cytochrome P450 system (induction of CYP 3A4 and 2C9) as well as the major drug transport protein – P-glycoprotein. As a result, St. John’s wort has major drug interactions, particularly with birth control pills, transplant rejection agents, antiretroviral agents, digoxin, platelet inhibitors, anticoagulants and psychotropic agents. Caution should be taken and specific interactions sought when using St. John’s wort with other medications.

### Hepatotoxicity

Despite wide spread use, there have been no convincing case reports linking use of St. John’s wort and hepatotoxicity. In controlled trials, St. John’s wort has not been linked to serum enzyme elevations or to clinically apparent liver injury. Because of its many herb-drug interactions and effects on the P450 system and drug transport and excretion, St. John’s wort may increase or decrease the likelihood of drug induced liver injury from other medications.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Goatweed, Hypericum

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

St. John’s Wort – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/stjohnswort/ataglance.htm)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
St. John’s Wort | 68917-49-7 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; St. John’s wort is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; St. John’s wort is listed as nonhepatotoxic).
St. John’s Wort. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 797-820. (Compilation of short monographs on herbal medications and dietary supplements).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications, including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and herb-drug interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; St. John’s wort is not discussed).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; St. John’s wort is not listed as causing hepatotoxicity).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to St. John’s wort).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals but none were attributed to St. John’s wort).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications; St. John’s wort is not listed).
Etogo-Asse F, Boemer F, Sempoux C, Geubel A. (2008). Acute hepatitis with prolonged cholestasis and disappearance of interlobular bile ducts following tibolone and Hypericum perforatum(St. John's wort). Case of drug interaction?. Acta Gastroenterol Belg. (57 year old woman developed jaundice 2 years after starting tibolone for menopausal symptoms and 10 weeks after starting St. John’s wort [bilirubin 6.3 rising to 37 mg/dL, ALT 424 U/L, Alk P 162 U/L, ANA 1:320], with prolonged jaundice and persistent Alk P elevations, biopsy showing paucity of bile ducts; authors suggest that St. John’s wort may have potentiated the hepatotoxicity of tibolone).
Wang N, Li P, Wang Y, Peng W, Wu Z, Tan S, Liang S, et al. (2008). Hepatoprotective effect of Hypericum japonicum extract and its fractions. J Ethnopharmacol. (Extracts of St. John’s wort provided partial protection against carbon tetrachloride injury in a rat model; fractionation of the extract suggested some of the effect was attributable to flavonoids).
Knüppel L, Linde K. (2004). Adverse effects of St. John's Wort: a systematic review. J Clin Psychiatry. (Systematic review of side effects of St. John’s wort, including 35 controlled trials found side effects were similar to those reported for placebo recipients and no serious adverse events were attributed to the herbal; case reports of adverse events included serotonin syndrome [18, with SSRIs], decrease in cyclosporine or tacrolimus levels after transplantation [16], increased INR on anticoagulants [13], phototoxicity [9] and allergic reactions [8]; among 722 reports to drug monitoring agencies, 24 [3%] were listed as hepatobiliary but no details were provided).
Gaster B, Holroyd J. (2000). St John's wort for depression: a systematic review. Arch Intern Med. (Systematic review of the literature concluded that St. John’s wort is more effective than placebo in treatment of mild-to-moderate depression and has a low rate of side effects, occurring in only 2.4% of 3250 patients in open label studies and at rates only mildly higher than with placebo [and in lower rates that with conventional antidepressants] in controlled trials; no mention of ALT elevations or hepatotoxicity).
Ernst E. (2004). Risks of herbal medicinal products. Pharmacoepidemiol Drug Saf. (Review of the adverse effects of over-the-counter herbal medications, focusing on the hepatotoxicity of kava, drug interactions with St. John’s wort, and contamination of traditional Chinese medications with heavy metals [arsensic, lead, mercury, thallium] and conventional western medications).
Jacobson JM, Feinman L, Liebes L, Ostrow N, Koslowski V, Tobia A, Cabana BE, et al. (2001). Pharmacokinetics, safety, and antiviral effects of hypericin, a derivative of St. John's wort plant, in patients with chronic hepatitis C virus infection. Antimicrob Agents Chemother. (19 patients with chronic hepatitis C were treated with purified hypericin orally for 8 weeks; there were no changes in HCV RNA or ALT levels, but skin photosensitivity reactions were common).
Domínguez Jiménez JL, Pleguezuelo Navarro M, Guiote Malpartida S, Fraga Rivas E, Montero Alvarez JL, Poyato González A. (2007). Gastroenterol Hepatol. (23 year old woman found to have chronic elevations in serum enzymes [ALT 48 to 265 U/L, GGT 28, Alk P 173 U/L] while taking St. John’s wort; results on stopping herbal were not provided).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; St. John's wort is not discussed).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry mentions 44 reactions to St. John's wort, but none were categorized as hepatic).
Choi YH, Chin YW, Kim YG. (2011). Herb-drug interactions: focus on metabolic enzymes and transporters. Arch Pharm Res. (Review of herb-drug interactions and their mechanistic basis; while in vitro studies suggest that St. John's wort might inhibit various P450 enzymes, in vivo studies show that it induces CYP 3A4, 1A and 2C9 as well as P-glycoprotein, leading to a lowering of serum levels of many drugs such as amitriptyline, cyclosporine, digoxin, fexofenadine, indinavir, methadone, midazolam, simvastatin, tacrolimus, theophylline and warfarin).
Chen XW, Sneed KB, Pan SY, Cao C, Kanwar JR, Chew H, Zhou SF. (2012). Herb-drug interactions and mechanistic and clinical considerations. Curr Drug Metab. (Review of literature on herb-drug interactions mentions that St. John's wort can lower concentrations of cyclosporine, tacrolimus, midazolam, digoxin, amitriptyline, indinavir, warfarin and theophylline).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements: St. John's wort is not discussed).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that St. John's wort is a potent inducer of CYP 3A4 and can cause clinically significant herb-drug interactions with warfarin, aspirin, cyclosporine, methotrexate, HIV protease inhibitors, and can potentiate the intrinsic hepatotoxicity of other agents such as acetaminophen).
Posadzki P, Watson L, Ernst E. (2013). Herb-drug interactions: an overview of systematic reviews. Br J Clin Pharmacol. (Review of systematic reviews of herb-drug interactions, mentions that St. John's wort can cause induction of CYP 3A and affect levels of several drugs; no mention of adverse hepatic effects).
Posadzki P, Watson LK, Ernst E. (2013). Adverse effects of herbal medicines: an overview of systematic reviews. Clin Med (Lond). (Systematic review of systematic reviews of adverse effects of herbals mentions that Hypericum perforatum has been associated only with minor adverse events).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, none of which were attributed to St. John’s wort).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, St. John’s wort was not implicated in any case).
Agollo MC, Miszputen SJ, Diament J. (2014). Hypericum perforatum-induced hepatotoxicity with possible association with copaiba (Copaifera langsdorffii Desf): case report. Einstein (Sao Paulo). (79 year old woman developed jaundice while taking St. John’s wort in addition to copaiba, glucosamine and chondroitin [bilirubin 9.0 mg/dL, ALT 1667 U/L], resolving rapidly once all medications were stopped).
Douros A, Bronder E, Andersohn F, Klimpel A, Kreutz R, Garbe E, Bolbrinker J. (2016). Herb-induced liver injury in the Berlin Case-Control Surveillance Study. Int J Mol Sci. (Among 198 patients with suspected drug induced liver injury seen at Berlin Hospitals and enrolled in a prospective database, 10 were attributed to herbal supplements including one case attributed to St. John’s wort, in a 65 year old woman who developed symptoms of liver injury without jaundice an unspecified time after starting St. John’s wort [bilirubin 2 times, ALT 19.2 times, Alk P 5.2 times ULN], resolving on stopping the supplement).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list St. John’s wort as implicated in any cases of liver injury).

## OTHER REFERENCE LINKS

1 Recent References on St. John’s Wort: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=St+John+Wort+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on St. John’s Wort: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=St+Johns+Wort)